# Ampicillin

## OVERVIEW

Ampicillin is an oral, third generation aminopenicillin and is used widely to treat mild-to-severe infections due to susceptible organisms. Ampicillin has been linked with idiosyncratic liver injury, but very rarely and largely in isolated case reports.

### Background

Ampicillin (am" pi sil' in) is an oral, third generation penicillin that is one of the most commonly used antibiotics worldwide. Ampicillin has been available in the United States since the mid-1960s and continues to be widely used for bacterial infections in both children and adults. Ampicillin is indicated for mild-to-severe upper respiratory tract infections caused by susceptible agents, such as (but not limited to) Escherichia coli, Hemophilus influenzae, Listeria monocytogenesis, Neisseria gonorrhoeae, Proteus mirabilis, Salmonella, Shigella, Staphylococcus aureus (non-penicillinase producing), Staphylococcus epidermidis, and Streptococcus pneumoniae. Ampicillin is also used for pneumonia, meningitis, endocarditis and uncomplicated gonorrhea. Ampicillin is available orally in multiple generic formulations as capsules of 250 and 500 mg and is usually given in doses of 250 to 500 mg every 6 to 8 hours for 7 to 14 days. Ampicillin is also available in parenteral form (intramuscular and intravenous) and recommended doses are 2 to 4 grams daily in divided doses given every 4 to 6 hours. Side effects are usually mild and self-limited and can include diarrhea, nausea and vomiting, fatigue, headache, and rash. Rare but potentially serious adverse events include hypersensitivity reactions, anaphylaxis, severe skin rash, Stevens Johnson syndrome, C. difficile diarrhea, neutropenia, aplastic anemia and thrombocytopenic purpura.

### Hepatotoxicity

The rate of serum aminotransferase and alkaline phosphatase elevations during ampicillin therapy is not well defined. High dose, intravenous ampicillin has been associated with ALT elevations in 9% to 11% of patients, but a similar rate is often found in comparator arms and the elevations are generally transient and asymptomatic. Rare instances of idiosyncratic liver injury have been reported in persons receiving the aminopenicillins, but they are rarely listed in large case series or prospective databases on drug-induced liver injury. The incidence of clinically apparent liver injury is far lower with ampicillin than occurs with amoxicillin, occurring probably in less than 1 in 200,000 exposed persons. Cases are characterized by a short latency period of a few days to as long as six weeks. The onset of liver injury can occur after the antibiotic is stopped. The serum enzyme pattern associated with aminopenicillin liver injury has included a hepatocellular pattern with marked elevations in ALT and AST, and minimal elevations in alkaline phosphatase and rapid recovery after withdrawal. In addition, cholestatic forms of hepatic injury with marked alkaline phosphatase elevations (as also seen with penicillin-induced liver injury) have also been described, some of which have been associated with prolonged cholestasis and, rarely, with vanishing bile duct syndrome. The onset of hepatic injury may be accompanied by skin rash, toxic epidermal necrolysis, or Stevens Johnson syndrome. Autoantibodies are uncommon.

Likelihood score: C (probable but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury associated with ampicillin use is probably hypersensitivity or allergy. Cases of recurrence upon rechallenge or reexposure have been reported.

### Outcome and Management

In the few cases of ampicillin related acute liver injury that have been described, most patients have recovered, although recovery has been slow in some cholestatic instances (2 to 6 months). Rare instances of acute liver failure and several cases of vanishing bile duct syndrome have been reported with ampicillin induced liver injury. Corticosteroids have often been used to treat the allergic manifestations and, while they may improve fever and rash promptly, their efficacy in ameliorating the accompanying liver disease has not been shown. Instances of recurrence of liver injury with reexposure to the aminopenicillins and recurrence with exposure to cephalosporins have been reported. Patients with aminopenicillin induced hepatitis should avoid reexposure to other penicillins and should take cephalosporins with caution.

Drug Class: Antiinfective Agents, Aminopenicillins

Other Drugs in the Subclass, Aminopenicillins: Amoxicillin, Amoxicillin-Clavulanate, Ampicillin-Sulbactam, Bacampicillin, Pivampicillin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ampicillin – Generic, Principen®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ampicillin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Ampicillin | 69-53-4 | C16-H19-N3-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 24 January 2026

Zimmerman HJ. Penicillins. In, Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams and Wilkins, 1999. p. 595-6. (Expert review of penicillins and liver injury published in 1999; the penicillins commonly lead to hypersensitivity reactions but rarely to liver injury).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that penicillins rarely cause liver injury and both hepatocellular and cholestatic patterns of injury have been described).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
Knirsch AK, Gralla EJ. Abnormal serum transaminase levels after parenteral ampicillin and carbenicillin administration. N Engl J Med 1970; 282: 1081-2. (Elevations in AST and CPK, but not ALT, occurred after intramuscular injections of ampicillin and carbenicillin, but not after cephalosporins or saline; thus, the elevations probably reflected muscle rather than liver injury). 5438429
McArthur JE, Dyment PG. Stevens-Johnson syndrome with hepatitis following therapy with ampicillin and cephalexin. N Z Med J 1975; 81: 390-2. (Stevens-Johnson syndrome developed in a 9 month old child given ampicillin [rash] and cephalexin, with subsequent hepatocellular injury [bilirubin 13 mg/dL], resolving with prednisone therapy). 1057088
Tamarkina AD, Dement'eva ES, Krylova NI, Minasova GS, Kuleshova EE. [Enzymological evaluation of the hepatotoxicity of ampicillin and its therapeutic form, roscillin, in the treatment of pyelonephritis in pregnancy] Antibiot Med Biotekhnol 1985; 30: 62-4. Russian. (Prospective analysis of serum enzyme levels in 12 patients receiving ampicillin found no changes during 12 days of therapy, although minor changes occurred when it was stopped). 3994343
Lees L, Milson JA, Knirsch AK, Greenhalgh K. Sulbactam plus ampicillin: interim review of efficacy and safety for therapeutic and prophylactic use. Rev Infect Dis 1986; 8 (Suppl 5): S644-S650. (Review of 45 studies of ampicillin-sulbactam in 899 patients found successful outcome in 92%; ALT elevations in 6.9%, AST in 6.2%, but all resolved with stopping and similar rates were reported with use of comparative agents). 3026019
Galante D, Esposito S, Barba D, Ruffilli MP. Clinical efficacy and safety of sulbactam/ampicillin in patients suffering from chronic liver disease. J Antimicrob Chemother 1987; 19: 527-32. (41 patients with advanced liver disease were given ampicillin-sulbactam: there was no worsening of liver disease or enzyme elevations attributed to medication). 3034850
Cavanzo FJ, Garcia CF, Botero RC. Chronic cholestasis, paucity of bile ducts, red cell aplasia, and the Stevens-Johnson syndrome. An ampicillin-associated case. Gastroenterology 1990; 99: 854-6. (A 35 year old woman developed Stevens-Johnson syndrome with cholestatic hepatitis and red cell aplasia 4 days after starting oral ampicillin and subsequently developed vanishing bile duct syndrome and prolonged cholestasis, but with gradual ultimate improvement after several years). 2116345
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports in Denmark from 1978 to 1987; no mention of aminopenicillins). 1506809
Köklü S, Yüksel O, Filik L, Usküdar O, Altundag K, Altiparmak E. Recurrent cholestasis due to ampicillin. Ann Pharmacother 2003; 37: 395-7. (23 year old man had recurrent bouts of liver injury 12, 8, and 5 days after starting three 7 day courses of ampicillin, last episode marked by bilirubin 2.1 mg/dL, ALT 265 U/L, and Alk P 455 U/L, resolving within 10 days of stopping). 12639171
Köklü S, Yüksel O, Yolcu OF, Arhan M, Altiparmak E. Cholestatic attack due to ampicillin and cross-reactivity to cefuroxime. Ann Pharmacother 2004; 38: 1539-40. (Follow up on 23 year old man in previous report, who redeveloped liver injury 17 days after starting a 10 day course of cefuroxime [bilirubin 0.7 mg/dL, ALT 427 U/L, Alk P 646 U/L], resolving within 2 months, suggesting cross sensitivity to hepatic injury between cephalosporins and ampicillin). 15266040
Köklü S, Köksal AS, Asil M, Kiyici H, Coban S, Arhan M. Probable sulbactam/ampicillin-associated prolonged cholestasis. Ann Pharmacother 2004; 38: 2055-8. (74 year old developed cholestatic hepatitis arising 1 week after 7 day course of ampicillin-sulbactam with prolonged jaundice [bilirubin 31 mg/dL, ALT 33 U/L, Alk P 519 U/L], resolving after 7 months, except mild GGT elevations). 15494387
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure; one case was attributed to amoxicillin-clavulanate, but none to penicillin, ampicillin or amoxicillin alone). 15390328
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 23 cases were attributed to amoxicillin-clavulanate, 2 cases to amoxicillin, but none to ampicillin). 18955056
Björnsson E, Davidsdottir L. The long-term follow-up after idiosyncratic drug-induced liver injury with jaundice. J Hepatol 2009; 50: 511-7. (Among 685 patients identified an average of 10 years after an episode of drug induced liver injury, 23 [3.4%] had continuing liver disease, 8 with cirrhosis; one patient who died of cirrhosis had liver injury attributed to ampicillin 3 years previously). 19155082
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; 3 [1%] were attributed to amoxicillin-clavulanate, but none were attributed to ampicillin or amoxicillin alone]. 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, including two attributed to amoxicillin but none to ampicillin; no details given). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, amoxicillin-clavulanate accounted for 38 cases [0.4%] for an adjusted odds ratio of 1.7, whereas neither amoxicillin or ampicillin alone were listed among the 41 most common causes [linked to at least 30 cases]). 21039766
Köksal AS, Yildiz H, Onder O, Avci S, Kayaåetin E. Sulbactam/ampicillin associated hepatocellular type liver injury. Acta Gastroenterol Belg 2012; 75: 66-7. (47 year old woman developed jaundice 8 days after a 4 day course of ampicillin-sulbactam [bilirubin 18.9 mg/dL, ALT 1344 U/L, Alk P 208 U/L], resolving within 10 weeks of stopping). 22567755
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, the most commonly implicated agent being amoxicillin-clavulanate [15 cases]; none were attributed to amoxicillin or ampicillin alone). 23419359
Sistanizad M, Peterson GM. Drug-induced liver injury in the Australian setting. J Clin Pharm Ther 2013; 38: 115-20. (Among 17 cases of suspected drug induced liver injury seen at a single referral hospital in Tasmania over a 12 month period, 11 were due to antibiotics including flucloxacillin in 4, amoxicillin in 2, amoxicillin-clavulanate in 2, and rifampin, moxifloxacin and ciprofloxacin in 1 each). 23350857
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Giaquinto C, Picelli G, Oteri A, et al. Idiopathic acute liver injury in paediatric outpatients: incidence and signal detection in two European countries. Drug Saf 2013; 36: 1007-16. (Analysis of 3 electronic healthcare databases from Italy and the Netherlands from 2000-2008 identified 785 cases of unexplained acute liver injury in children, linked to 110 possible medications, with increased adjusted relative risk [RR] of recent exposure to amoxicillin-clavulanate [RR=18.6] and amoxicillin [RR=7.5]). 23591830
Lim R, Choudry H, Conner K, Karnsakul W. A challenge for diagnosing acute liver injury with concomitant/sequential exposure to multiple drugs: can causality assessment scales be utilized to identify the offending drug? Case Rep Pediatr 2014; 2014: 156389. (12 year old boy was treated with oral ampicillin for suspected Streptococcal sore throat and developed evidence of neck cellulitis and was treated with intravenous ampicillin-sulbactam, vancomycin, and oral clindamycin at which point he developed jaundice [bilirubin 3.0 mg/dL, ALT 406 U/L, Alk P 404 U/L, INR 1.1] and was continued on ampicillin-sulbactam, developing rash and deep and prolonged jaundice and itching which lasted 5 months and resolved, but with persistence of alkaline phosphatase elevations, the causative agent being unclear but most likely ampicillin-sulbactam). 25506455
Kaye JA, Castellsague J, Bui CL, Calingaert B, McQuay LJ, Riera-Guardia N, Saltus CW, et al. Risk of acute liver injury associated with the use of moxifloxacin and other oral antimicrobials: a retrospective, population-based cohort study. Pharmacotherapy 2014; 34: 336-49. (In a US healthcare database with 1.3 million antimicrobial users, there were 607 cases of liver injury and 11 cases of liver failure, the highest relative risk for current single use being 3.2 for levofloxacin, 2.5 for amoxicillin-clavulanate, 2.5 for doxycycline, 2.3 for moxifloxacin, and 2.3 for amoxicillin). 24865821
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, including one to benzathine penicillin and 3 to amoxicillin-clavulanate, but none to other penicillins). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics of which 106 [12%] were due to penicillins including one to 1st, three to 2nd [all due to oxacillin], 97 to 3rd [91 to amoxicillin-clavulanate, and 6 to amoxicillin alone] and five to 4th generation penicillins [all 5 to piperacillin-tazobactam]; none were attributed to ampicillin). 25754159
Guéant JL, Romano A, Cornejo-Garcia JA, Oussalah A, Chery C, Blanca-López N, Guéant-Rodriguez RM, et al. HLA-DRA variants predict penicillin allergy in genome-wide fine-mapping genotyping. J Allergy Clin Immunol 2015; 135: 253-9. (In a genome wide association study of 387 patients with immediate allergic reactions to beta-lactam antibiotics, several class 2 HLA associations [HLA-DRA regions] were found for penicillin responses, but they did not apply to cephalosporin cases). 25224099
Björnsson ES. Drug-induced liver injury: an overview over the most critical compounds. Arch Toxicol 2015; 89: 327-34. (Review of the most common causes of drug induced liver injury in 3 recent surveys, all of which listed amoxicillin-clavulanate as the most frequent cause; none listed other penicillins). 25618544
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol 2015; 136: 1288-94.e1. (Among 824 patients who underwent outpatient parenteral antibiotic therapy for at least 2 weeks, 210 [25%] developed eosinophilia including 58 of 207 [28%] who received “penicillins” of whom 3 developed signs of “possible” DRESS syndrome; specific penicillins accounting for the cases were not provided). 25981739
Nicoletti P, Aithal GP, Bjornsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al.; International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology 2017; 152: 1078-89. (A genome wide association study done on 862 Caucasian patients with drug induced liver injury demonstrated a strong link with HLA-A*33:01 in those with cholestatic liver injury, particularly in cases attributed to terbinafine, fenofibrate and ticlopidine). 28043905
Munz M, Grummich H, Birkmann J, Wilhelm M, Holzgrabe U, Sörgel F. Severe drug-Induced liver injury as an adverse drug event of antibiotics: a case report and review of the literature. Chemotherapy 2017; 62: 367-73. (20 year old woman received 4 antibiotics [amoxicillin, ciprofloxacin, cefazolin, and clindamycin] and acetaminophen within weeks of developing rash, fever and jaundice [bilirubin 3.7 mg/dL, ALT 1219 U/L, Alk P 143 U/L, GGT 201 U/L, INR 1.6], with worsening and signs of hepatic failure but subsequent spontaneous and complete resolution, the specific cause being obscure because of polypharmacy). 28934748
Takeuchi Y, Shinozaki T, Kumamaru H, Hiramatsu T, Matsuyama Y. Analyzing intent-to-treat and per-protocol effects on safety outcomes using a medical information database: an application to the risk assessment of antibiotic-induced liver injury. Expert Opin Drug Saf 2018; 17: 1071-9. (Cohort matching of cases with vs without antibiotic therapy in a large electronic medical record database from the University of Tokyo Hospital from 2011 to 2015 with adjustments found rates of liver test abnormalities within 30 days of starting penicillins [25.2 per 1000] was higher than that with fluoroquinolones [11.4], macrolide antibiotics [8.1], as well as controls [6.5 to 7.1]). 30252549
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Bjornsson ES, Chalasani N, Fontana RJ, et al.; Drug-Induced Liver Injury Network (DILIN) investigators; International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology 2019; 156: 1707-16.e2. (Genome wide association studies on 2048 patients with drug induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions). 30664875
Alhaddad O, Elsabaawy M, Abdelsameea E, Abdallah A, Shabaan A, Ehsan N, Elrefaey A, et al. Presentations, causes and outcomes of drug-induced liver injury in Egypt. Sci Rep. 2020;10:5124. (Among 75 patients with drug-induced liver injury seen at an Egyptian referral center between 2015 and 2016, 56 [71%] were in patients with chronic hepatitis C, and the most common causes were diclofenac [41%], amoxicillin-clavulanate [19%], halothane [11%], ibuprofen [5%], and khat [4%]; none were due to ampicillin or other aminopenicillins). 32198411
Suzuki T, Sugiyama E, Nozawa K, Tajima M, Takahashi K, Yoshii M, Suzuki H, et al. Effects of dosing frequency on the clinical efficacy of ampicillin/sulbactam in Japanese elderly patients with pneumonia: A single-center retrospective observational study. Pharmacol Res Perspect. 2021;9:e00746. (Among 106 patients 70 years or older with pneumonia treated with intravenous ampicillin-sulbactam in doses of 6 gm given either 2 vs 4 times daily, the clinical response rate was 36% vs 56% while adverse event rates were similar, ALT elevations arising in 16% of both groups which were above 3 times ULN in 1 vs 2 participants and with no episodes of clinically apparent liver injury). 33764686
Guo YM, Ge FL, Song HB, Xiong P, Jing J, Niu M, Zhao X, et al. Relative risk analysis of liver-related adverse drug reactions in children based on China's National Spontaneous Reporting System. J Pediatr. 2021;234:85-91. (Among 1206 pediatric liver related adverse events reported to the China National Spontaneous Reporting System, the most frequently implicated agents were anti-tuberculosis agents [283 cases], methotrexate [140], and azithromycin [130], while amoxicillin-clavulanate was implicated in 22, amoxicillin alone 14, ampicillin 1, ampicillin-sulbactam none). 33794217
Fowler C, Namtu K. Ampicillin-sulbactam-induced liver injury in a pediatric patient. J Pediatr Pharmacol Ther. 2023;28:747-751. (12 year old boy with seizures, developmental delay, and recurrent aspiration pneumonia developed respiratory failure and pleural effusion and was treated with ampicillin-sulbactam [2 gm 4 times daily] and developed worsening liver tests which peaked at day 5 [bilirubin direct/total 0.8/1.2 mg/dL, ALT 1328 U/L, AST 2171 U/L, INR 2.1] which began to resolve with stopping ampicillin-sulbactam, considered the cause although ischemic hepatitis was also likely). 38094676
Nicoletti P, Dellinger A, Li YJ, Barnhart HX, Chalasani N, Fontana RJ, Odin JA, et al; Drug-Induced Liver Injury Network (DILIN); International Drug-Induced Liver Injury Consortium (iDILIC); Prospective European Drug-Induced Liver Injury (Pro-Euro DILI) Investigators. Identification of reduced ERAP2 expression and a novel HLA allele as components of a risk score for susceptibility to liver injury due to amoxicillin-clavulanate. Gastroenterology. 2023;164:454-466. (Genome and transcriptome wide association studies on 444 patients with liver injury from amoxicillin-clavulanate vs 10,397 controls identified 3 HLA region risk alleles [A*02:01, B*14:01, and DRB1*15:01], and 2 non-HLA risk variants [in ERAP2 and PTPN22]; the combination of all 5 being applicable in a sensitive genetic risk score; ampicillin cases were too few and not evaluated) 36496055
Gu S, Rajendiran G, Forest K, Tran TC, Denny JC, Larson EA, Wilke RA. Drug-induced liver injury with commonly used antibiotics in the All of Us Research Program. Clin Pharmacol Ther. 2023;114:404-412. (Among patients enrolled in a prospective study of genetics and health who had been exposed to various drugs, electronic medical records identified 30 attributable to amoxicillin-clavulanate, 22 to amoxicillin, but drugs with fewer than 20 cases, such as ampicillin, were not mentioned). 37150941
Medina-Cáliz I, Sanabria-Cabrera J, Villanueva-Paz M, Aukštikalnė L, Stephens C, Robles-Díaz M, Pinazo-Bandera JM, et al. Characterization of drug-induced liver injury associated with drug reaction with eosinophilia and systemic symptoms in two prospective DILI registries. Arch Toxicol. 2024;98:303-325. (Among 1437 patients enrolled in the Spanish and Latin American registries of drug-induced liver injury, 53 [3.7%] developed DRESS syndrome, the most common causes were carbamazepine [13%], anti-tuberculous agents [13%], amoxicillin-clavulanate [11%], allopurinol [8%], and lamotrigine [8%]: no case of ampicillin developed DRESS). 38051367
Ooi H, Asai Y, Sato Y. Risk evaluation of ampicillin/sulbactam-induced liver injury based on albumin-bilirubin score. J Infect Chemother. 2023;29:900-904.. (Among 380 patients treated with ampicillin-sulbactam at a single Japanese referral center, 36 [9.5%] developed ALT or Alk P elevations above twice ULN during or shortly after therapy, no mention of symptoms or concurrent bilirubin levels). 37301371
Pinazo-Bandera JM, Niu H, Alvarez-Alvarez I, Medina-Cáliz I, Del Campo-Herrera E, Ortega-Alonso A, Robles-Díaz M, et al. Rechallenge in idiosyncratic drug-induced liver injury: An analysis of cases in two large prospective registries according to existing definitions. Pharmacol Res. 2024;203:107183.. (Among 1418 patients enrolled in the Spanish and Latin American registries of drug-induced liver injury, 58 had a positive rechallenge response including 10 due to amoxicillin-clavulanate and 1 due to amoxicillin, but no mention of ampicillin or other penicillins). 38631619
Ishikawa K, Kobayashi D, Mori N. Adverse events comparison of double beta-lactam combinations for bloodstream infections: ampicillin plus ceftriaxone and ampicillin/cloxacillin. Antibiotics (Basel). 2024;13:696. (Analysis of adverse events in 277 patients hospitalized with infections receiving ampicillin-sulbactam alone vs 57 receiving it combined with a cephalosporin vs 43 receiving it combined with cloxacillin revealed ALT elevations above 3 times ULN in 9.5% vs 19.3% vs 16.3% which were above 5 times ULN in 3.6% vs 8.8% vs 9.3%; no mention of concurrent bilirubin elevations or clinically apparent liver injury). 39199996
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 58 [14%] were attributed to amoxicillin-clavulanate, 2 [0.5%] to amoxicillin alone, and only 1 to ampicillin; clinical details not given). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 191 cases [15%; incidence 1:2,400] attributed to amoxicillin-clavulanate, but only 15 [1.3%: incidence 1:170,000] to amoxicillin alone, and none to ampicillin).

## OTHER REFERENCE LINKS

1. Recent References on Ampicillin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=ampicillin/AE%5BMH:noexp%5D+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ampicillin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ampicillin)